# Eliglustat

## OVERVIEW

### Introduction

Eliglustat is an oral inhibitor of glucosylceramide synthase which is used in the therapy of type 1 Gaucher disease. Clinical experience with eliglustat is limited, but it not been linked to serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Eliglustat (el" i gloo' stat) is a small molecule inhibitor of glucosylceramide synthase, the first and rate controlling step in the pathway of glycolipid synthesis. By inhibiting the pathway, lower levels of gylcolipid substrates are available, so that less of the substrate is available for lysosomal degradation and less glycosylceramide accumulates. Eliglustat was shown to decrease the intracellular accumulation of glycosylceramide in animal models of Gaucher disease. In several randomized controlled trials, eliglustat was shown to decrease spleen and liver volume and increase hemoglobin and platelet counts in patients with type 1 Gaucher disease. Eliglustat was also able to maintain clinical benefit in patients who had been maintained on long term enzyme replacement therapy with glucocerebrosidase infusions (the lysosomal enzyme that is deficient in type 1 Gaucher disease). Eliglustat was approved as oral therapy of type 1 Gaucher Disease in the United States in 2015. Eliglustat is metabolized by the microsomal enzyme CYP 2D6 and serum levels are markedly affected by different CYP 2D6 isoenyzmes, so that it is recommended only for patients who are extensive, intermediate or poor metabolizers of CYP 2D6 and not for ultra-rapid metabolizers or patients who have an indeterminant or unknown metabolizer status. Eliglustat is available in tablets of 84 mg and the usual dose is 84 mg twice daily, but major dose adjustments are recommended for patients taking inhibitors of CYP 3A or 2D6. Side effects can include fatigue, headache, nausea, diarrhea, back pain and muscle aches.

### Hepatotoxicity

In placebo controlled trials, liver test abnormalities were no more common with eliglustat than with placebo treatment, and what abnormalities occurred were mild and resolved spontaneously usually without need for dose interruption. During these premarketing clinical trials and since its more widespread clinical availability, no instances of acute liver injury with jaundice have been reported attributable to eliglustat. However, the total clinical experience with eliglustat use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury, but experience with its use is limited).

### Mechanism of Injury

The mechanism by which eliglustat might cause serum aminotransferase elevations or liver injury is not known. Eliglustat is extensively metabolized by the liver via the cytochrome P450 system (predominantly CYP 2D6 and 3A) and is susceptible to drug-drug interactions with agents that induce or inhibit these enzymes.

### Outcome and Management

The serum aminotransferase elevations that occur on eliglustat therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to eliglustat have been reported.

Drug Class: Gaucher Disease Agents

Other Drugs in the Class: Miglustat, Glucocerebrosidase (Enzyme Replacement Therapy)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Eliglustat – Cerdelga®

DRUG CLASS

Gaucher Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Eliglustat)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Eliglustat | 491833-29-5 | C23-H36-N2-O4 | Eliglustat chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 05 March 2018

Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics; eliglustat is not discussed).
McEachern KA, Fung J, Komarnitsky S, Siegel CS, Chuang WL, Hutto E, Shayman JA, et al. A specific and potent inhibitor of glucosylceramide synthase for substrate inhibition therapy of Gaucher disease. Mol Genet Metab 2007; 91: 259-67. (Description of a novel glucosylceramide synthase inhibitor [Genz-112738: eliglustat] that inhibits the intracellular enzyme in normal cells, and decreases glucosylceramide accumulation in cells of mouse models of Gaucher disease with no appreciable toxicity providing a substrate inhibition approach to therapy). 17509920
Lukina E, Watman N, Arreguin EA, Dragosky M, Iastrebner M, Rosenbaum H, Phillips M, et al. Improvement in hematological, visceral, and skeletal manifestations of Gaucher disease type 1 with oral eliglustat tartrate (Genz-112638) treatment: 2-year results of a phase 2 study. Blood 2010; 116: 4095-8. (Among 20 adults with type 1 Gaucher disease treated with eliglustat for at least 2 years, there were clinically important improvements in hemoglobin and platelet count and decreases in spleen and liver size with minimal side effects; no mention of ALT elevations or hepatotoxicity). 20713962
Lukina E, Watman N, Dragosky M, Pastores GM, Arreguin EA, Rosenbaum H, Zimran A, et al. Eliglustat, an investigational oral therapy for Gaucher disease type 1: Phase 2 trial results after 4 years of treatment. Blood Cells Mol Dis 2014; 53: 274-6. (Among 26 patients with type 1 Gaucher disease treated with eliglustat for up to 4 years, clinical improvements were maintained and there were increasing improvements in bone density; adverse events were largely unrelated to therapy; no mention of ALT elevations or hepatotoxicity). 24835462
Eliglustat (Cerdelga)--an oral drug for Gaucher disease. Med Lett Drugs Ther 2015; 57 (1472): e100-1. (Concise review of the mechanism of action, clinical efficacy, safety, drug-drug interactions and costs of eliglustat shortly after its approval in the US, mentions side effects of fatigue, headache, nausea, diarrhea and back pain, but does not mention ALT elevations or hepatotoxicity). 26147895
Mistry PK, Lukina E, Ben Turkia H, Amato D, Baris H, Dasouki M, Ghosn M, et al. Effect of oral eliglustat on splenomegaly in patients with Gaucher disease type 1: the ENGAGE randomized clinical trial. JAMA 2015; 313: 695-706. (Among 40 patients with type 1 Gaucher disease treated with eliglustat or placebo for 9 months, hemoglobin and platelet counts increased and liver and spleen size decreased on eliglustat, but not on placebo and there were no severe adverse events attributable to therapy; no mention of ALT elevations or hepatotoxicity). 25688781
Cox TM, Drelichman G, Cravo R, Balwani M, Burrow TA, Martins AM, Lukina E, et al. Eliglustat compared with imiglucerase in patients with Gaucher's disease type 1 stabilised on enzyme replacement therapy: a phase 3, randomised, open-label, non-inferiority trial. Lancet 2015; 385 (9985): 2355-62. (Among 106 patients with stable type 1 Gaucher disease on long term enzyme replacement therapy who were switched to eliglustat or maintained on imiglucerase for 12 months, clinical features were stable in both groups, while side effects more frequent with eliglustat included diarrhea, fatigue, nausea, headache, dyspepsia and abdominal pain; no mention of ALT elevations or hepatotoxicity, but one patient developed hepatocellular carcinoma). 25819691
Mistry PK, Lukina E, Ben Turkia H, Shankar SP, Baris H, Ghosn M, Mehta A, et al. Outcomes after 18 months of eliglustat therapy in treatment-naïve adults with Gaucher disease type 1: The phase 3 ENGAGE trial. Am J Hematol 2017; 92: 1170-6. (Among 40 patients with Gaucher disease treated with eliglustat or placebo for 9 months, spleen size decreased [-28% vs +3%] and platelet counts increased [+32% vs -9%], while there were no serious adverse events in either group and no "clinically meaningful worsening" of routine laboratory test results). 28762527
Cox TM, Drelichman G, Cravo R, Balwani M, Burrow TA, Martins AM, Lukina E, et al. Eliglustat maintains long-term clinical stability in patients with Gaucher disease type 1 stabilized on enzyme therapy. Blood 2017; 129: 2375-83. (Among 157 patients with Gaucher diseae who were enrolled in a long term extension study after a one year controlled trial of eliglustat vs imiglucerase [Cox 2015], liver and spleen size, hemoglobin and platelet counts were stable for 1-4 years of therapy and there were no serious adverse events or drug discontinuations for ALT elevations or acute hepatotoxicity). 28167660
Peterschmitt MJ, Cox GF, Ibrahim J, MacDougall J, Underhill LH, Patel P, Gaemers SJM. A pooled analysis of adverse events in 393 adults with Gaucher disease type 1 from four clinical trials of oral eliglustat: evaluation of frequency, timing, and duration. Blood Cells Mol Dis 2018; 68: 185-91. (Among 393 patients with Gaucher disease treated with eliglustat in 4 clinical trials, there were no serious adverse events or drug discontinuations because of ALT elevations or acute liver injury). 28126395
Charrow J, Fraga C, Gu X, Ida H, Longo N, Lukina E, Nonino A, Gaemers SJM, Jouvin MH, Li J, Wu Y, Xue Y, Peterschmitt MJ. Once- versus twice-daily dosing of eliglustat in adults with Gaucher disease type 1: The Phase 3, randomized, double-blind EDGE trial. Mol Genet Metab 2018; 123: 347-56. (Among 170 adults with Gaucher disease treated with once or twice daily eliglustat for a median of 3.3 years, all deaths [n=2] were unrelated and there were no liver related severe adverse events or liver adverse event related discontinuations). 29358012
Zimran A, Belmatoug N, Bembi B, Deegan P, Elstein D, Fernandez-Sasso D, Giraldo P, et al.; GOS Study group. Demographics and patient characteristics of 1209 patients with Gaucher disease: Descriptive analysis from the Gaucher Outcome Survey (GOS). Am J Hematol 2018; 93: 205-12. (Summary of clinical features of 1209 patients [95% type 1] enrolled in an international Gaucher disease registry between 2010 and 2017, including 887 [73%] who received at least one therapy, most commonly imiglucerase [66%], velaglucerase [57%], alglucerase [12%], taliglucerase [10%] and miglustat [10%], does not mention eliglustat, adverse events or liver related complications of treatment). 29090476

## OTHER REFERENCE LINKS

1. Recent References on Eliglustat: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Eliglustat+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Eliglustat: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Eliglustat)